# Toremifene

## OVERVIEW

### Introduction

Toremifene is a nonsteroidal antiestrogen that is used in the treatment of estrogen receptor positive breast cancer. Long term toremifene therapy has been associated with development of fatty liver, steatohepatitis, cirrhosis, and rare instances of clinically apparent acute liver injury.

### Background

Toremifene (tor em' i feen) is a selective estrogen receptor modulator, similar to tamoxifen, that has tissue specific actions with antiestrogenic activity on breast tissue, but estrogenic activity (agonism) on bone and the cardiovascular system. The antiestrogenic effects of toremifene are the basis for its use in the treatment of estrogen-receptor positive breast cancer. It also has weak estrogenic effects on uterus. Toremifene was approved for use in the United States in 1997 and its indications are limited to the treatment of estrogen-receptor positive (or unknown) metastatic breast cancer in postmenopausal women. Unlike tamoxifen, toremifene has not been approved as a means of prevention of de novo breast cancer in high risk patients or for prevention of recurrence of breast cancer. Toremifene is available in tablets of 60 mg under the brand name Fareston. The recommended dose is 60 mg by mouth once daily. Common side effects include hot flashes, sweating, nausea, dizziness, peripheral edema and vaginal discharge. Rare, but potentially severe adverse events include tumor flare (transient worsening soon after starting therapy), prolongation of the QTc interval, venous thrombosis and pulmonary embolism and endometrial (uterine) carcinoma.

### Hepatotoxicity

Toremifene has been associated with mild-to-moderate serum ALT or AST elevations in 5% to 19% of patients, but these abnormalities are usually transient and not associated with symptoms or jaundice. Elevations above 5 times the ULN are uncommon (<1%), but occasionally lead to discontinuation. In large registration clinical trials, there were no instances of clinically apparent liver injury attributed to toremifene therapy. Since its approval and more wide spread use, toremifene has been associated with instances of nonalcoholic fatty liver with serum enzyme elevations, some cases of which were shown to represent steatohepatitis. Both the serum enzyme elevations and fatty liver tended to regress once therapy was stopped and no instances of cirrhosis or death from end stage liver disease have been linked to toremifene therapy in the published literature. Nevertheless, steatohepatitis, cirrhosis, end stage liver disease and hepatocellular carcinoma have been reported in women treated with tamoxifen for many years and similar instances may occur with toremifene, although the hepatic adverse effects of the estrogen receptor modulators appears to be less with toremifene than with tamoxifen.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum enzyme elevations during toremifene therapy is unknown, but they may represent fatty liver disease induced by the estrogen receptor modulation. Toremifene is metabolized in the liver by CYP 3A4 and is susceptible to drug-drug interactions with agents that induce, inhibit or are substrates for this microsomal enzyme.

### Outcome and Management

While fatty liver arises in proportion of women treated with toremifene, clinically significant steatohepatitis is rare. Nevertheless, periodic monitoring of serum aminotransferase levels during toremifene therapy is appropriate. In women with persistent elevations in ALT levels, the relative benefits and risks of continuing toremifene therapy must be weighed. Factors to help in the decision include noninvasive tests for hepatic fibrosis (platelet count), imaging of the liver and, in some instances, liver biopsy. Other approaches short of stopping toremifene therapy include nutritional advice and weight loss, abstinence from alcohol, and possibly medical therapies for nonalcoholic steatohepatitis (which are currently investigational and have not been shown to be specifically helpful in drug induced fatty liver). The possible development of serious hepatic fibrosis and portal hypertension can be assessed noninvasively by serial determinations of platelet count, but may require liver biopsy to document.

Drug Class: Antineoplastic Agents, Hormonal Agents, Antiestrogens, Selective Estrogen Receptor Modulators

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Toremifene – Fareston®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Toremifene)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Toremifene | 89778-26-7 | C26-H28-Cl-N-O | Toremifene chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2016

Zimmerman HJ. Antiestrogens. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 574. (Expert review of hepatotoxicity published in 1999 mentions that tamoxifen can lead to cholestasis, peliosis, fatty liver and steatohepatitis, but does not discuss toremifene).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of SERMs mentions that hepatic effects including fatty liver disease are less common with toremifene than tamoxifen).
Moy B, Lee RJ, Smith M. Anti-estrogen therapy. Natural products in cancer chemotherapy. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1756-9. (Textbook of pharmacology and therapeutics).
Kivinen S, Mäenpää J. Effect of toremifene on clinical chemistry, hematology and hormone levels at different doses in healthy postmenopausal volunteers: phase I study. J Steroid Biochem 1990; 36: 217-20. (Toremifene given in a single dose for 5 days in 72 postmenopausal women was associated with a decrease in serum ALT, AST and Alk P). 2142236
Systemic treatment of early breast cancer by hormonal, cytotoxic, or immune therapy. 133 randomised trials involving 31,000 recurrences and 24,000 deaths among 75,000 women. Early Breast Cancer Trialists' Collaborative Group. Lancet 1992; 339: 1-15, 71-85. (Combined results of outcome of tamoxifen therapy in 75,000 women showed reductions in rates of recurrence and death and decrease in cancer in contralateral breast for first 4 years of therapy). 1345869
Vogel CL, Shemano I, Schoenfelder J, Gams RA, Green MR. Multicenter phase II efficacy trial of toremifene in tamoxifen-refractory patients with advanced breast cancer. J Clin Oncol 1993; 11: 345-50. (Among 102 women with metastatic breast cancer refractory to tamoxifen, the objective response rate to toremifene was 5% and AST elevations above 100 U/L arose in 9% of patients, but there was no mention of clinically apparent liver injury). 8426212
Plowman PN. Tamoxifen as adjuvant therapy in breast cancer. Drugs 1993; 46: 819-33. (Review of the history, mechanism of action, clinical efficacy and toxicity of tamoxifen; common side effects are vasomotor symptoms, vaginal discharge and endometrial hyperplasia, and rare serious side effects include endometrial carcinoma, ocular toxicity and increased thromboses; hepatotoxicity not discussed). 7505033
Hayes DF, Van Zyl JA, Hacking A, Goedhals L, Bezwoda WR, Mailliard JA, Jones SE, et al. Randomized comparison of tamoxifen and two separate doses of toremifene in postmenopausal patients with metastatic breast cancer. J Clin Oncol 1995; 13: 2556-66. (Among 648 women with estrogen receptor positive metastatic breast cancer treated with tamoxifen [20 mg] or toremifene [60 or 200 mg] daily, response rates were similar [44-50%] as were adverse events such as tumor flare [16-19%], nausea [14-20%], edema [5-8%], hot flashes [28-34%], and vaginal discharge [13-16%], whereas AST elevations above 100 U/L were more common with toremifene [5-10%] than tamoxifen [2%] and led to discontinuations in 2 patients). 7595707
Pyrhönen S, Valavaara R, Modig H, Pawlicki M, Pienkowski T, Gundersen S, Bauer J, et al. Comparison of toremifene and tamoxifen in post-menopausal patients with advanced breast cancer: a randomized double-blind, the 'nordic' phase III study. Br J Cancer 1997; 76: 270-7. (Among 415 postmenopausal women with metastatic breast cancer, overall response rates were 31% with toremifene [60 mg] vs 37% with tamoxifen [40 mg], and adverse event rates were 39% vs 44% including AST elevations in 3% vs 8%; however, no patient developed clinically apparent liver injury). 9231932
Gershanovich M, Garin A, Baltina D, Kurvet A, Kangas L, Ellmén J. A phase III comparison of two toremifene doses to tamoxifen in postmenopausal women with advanced breast cancer. Eastern European Study Group. Breast Cancer Res Treat 1997; 45: 251-62. (Among 463 postmenopausal women with advanced breast cancer, the overall response rate as 20-29% with toremifene [60 and 240 mg] vs 21% with tamoxifen [40 mg] daily and tolerability was similar between the lower doses of the two SERMs). 9386869
Fisher B, Constantino JP, Wickerham DL, Redmond CK, Kavanah M, Cronin WM, Vogel V, et al. Tamoxifen for prevention of breast cancer: report of the National Surgical Adjuvant Breast and Bowel Project P-1 Study. J Natl Cancer Inst 1998; 90: 1371-88. (Among 13,388 women at increased risk for breast cancer treated with tamoxifen or placebo for 5 years, tamoxifen reduced risk of cancer by 49% [22 vs 43.4/1000]; hepatotoxicity was not mentioned, but there were no cases of liver cancer or deaths from liver disease in either group). 9747868
Ogawa Y, Murata Y, Nishioka A, Inomata T, Yoshida S. Tamoxifen-induced fatty liver in patients with breast cancer. Lancet 1998; 351: 725. (Fatty liver found by computed tomography in 24 of 66 [36%] patients with breast cancer treated with tamoxifen). 9504521
Toremifene and letrozole for advanced breast cancer. Med Lett Drugs Ther 1998; 40 (1024): 43-5. (Short summary of the mechanism of action, clinical efficacy, adverse events and costs of toremifene shortly after its approval for use in the United States mentions that serum aminotransferase elevations have been reported in patients on therapy). 9580744
Law CH, Tandan VR. The association between tamoxifen and the development of hepatocellular carcinoma: case report and literature review. Can J Surg 1999; 42: 211-4. (56 year old woman developed hepatocellular carcinoma an unspecified time after a 6 year course of tamoxifen for breast cancer, having no other risk factors and normal nontumorous liver histology). 10372018
Moffat DF, Oien KA, Dickson J, Habeshaw T, McLellan DR. Hepatocellular carcinoma after long-term tamoxifen therapy. Ann Oncol 2000; 11: 1195-6. (71 year old woman with breast cancer developed abdominal pain and hepatocellular carcinoma after 12 years of tamoxifen therapy [AST 145 U/L, Alk P 378 U/L, alpha fetoprotein 320 ng/dL]; no mention of weight or hepatitis serology). 11061618
Hamada N, Ogawa Y, Saibara T, Murata Y, Kariya S, Nishioka A, Terashima M, et al. Toremifene-induced fatty liver and NASH in breast cancer patients with breast-conservation treatment. Int J Oncol 2000; 17: 1119-23. (Among 52 women with breast cancer treated with toremifene for 3 to 5 years, 4 [8%] developed fatty liver disease by CT scan, 2 with raised ALT and AST levels and one with steatohepatitis on liver biopsy). 11078796
Farrell GC. Drugs and steatohepatitis. Semin Liver Dis 2002; 22: 185-94. (Review of drug induced steatohepatitis; tamoxifen has been associated with fatty liver, steatohepatitis and cirrhosis usually arising after 1-2 years of therapy and improving upon stopping treatment; mentions that toremifene also has been reported to cause steatosis and steatohepatitis, but at a lower frequency [<10%] than tamoxifen). 12016549
Agarwal R, Peters TJ, Coombes RC, Vigushin DM. Tamoxifen-related porphyria cutanea tarda. Med Oncol 2002; 19: 121-3. (58 year old woman developed porphyria cutanea tarda after four years of tamoxifen therapy for breast cancer [bilirubin 0.5 mg/dL, ALT 48 U/L, Alk P 84 U/L] with no iron overload, hepatitis C or alcohol abuse, symptoms and liver tests improving on stopping tamoxifen). 12180481
Ellmén J, Hakulinen P, Partanen A, Hayes DF. Estrogenic effects of toremifene and tamoxifen in postmenopausal breast cancer patients. Breast Cancer Res Treat 2003; 82: 103-11. (Among 648 women with breast cancer treated with toremifene or tamoxifen, AST levels did not change in those receiving 60 mg of toremifene or 20 mg of tamoxifen daily). 14692654
Nishino M, Hayakawa K, Nakamura Y, Morimoto T, Mukaihara S. Effects of tamoxifen on hepatic fat content and the development of hepatic steatosis in patients with breast cancer: high frequency of involvement and rapid reversal after completion of tamoxifen therapy. Am J Roentgenol 2003; 180: 129-34. (Among 67 women with breast cancer treated with tamoxifen followed with annual CT scans of the liver, 43% developed steatosis, all within 2 years, which was severe in 6% and which improved to baseline after therapy; no patient developed cirrhosis). 12490491
Bruno S, Maisonneuve P, Castellana P, Rotmensz N, Rossi S, Maggioni M, Persico M, et al. Incidence and risk factors for non-alcoholic steatohepatitis: prospective study of 5408 women enrolled in Italian tamoxifen chemoprevention trial. BMJ 2005; 330: 932. (Among 5408 Italian women with breast cancer treated with tamoxifen or placebo for 5 years, 64 developed persistent de novo elevations in serum ALT which was attributable to fatty liver in 52 [control 0.7% vs tamoxifen 1.3%]; hazard ratio [HR] for fatty liver was 2.0 for tamoxifen, but association was limited to overweight [HR 3.2] or obese [HR 5.4] women and none developed signs of cirrhosis). 15746106
Grieco A, Forgione A, Miele L, Vero V, Greco AV, Gasbarrini A, Gasbarrini G. Fatty liver and drugs. Eur Rev Med Pharmacol Sci 2005; 9: 261-3. (Brief review of drugs that can cause steatosis including amiodarone and tamoxifen, but not toremifene). 16237810
Omoto H, Yamashita S, Ito H. [A Case of Liver Failure Induced by Toremifene in a Patient with Metastatic Breast Cancer]. Gan To Kagaku Ryoho 2015; 42: 1809-11. Japanese. (67 year old woman with metastatic breast cancer developed jaundice 4 months after starting toremifene which led to liver failure and was attributed to the antiestrogen therapy). 26805180
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to a selective estrogen receptor modulator). 23419359
Vogel CL, Johnston MA, Capers C, Braccia D. Toremifene for breast cancer: a review of 20 years of data. Clin Breast Cancer 2014; 14: 1-9. (Review of the safety and efficacy of toremifene mentions that safety data is based upon more than 500,000 patients-years of experience and that adverse events rates are similar between toremifene and tamoxifen, and that AST elevations occur in 5-19% on toremifene vs 1-17% on tamoxifen). 24439786
Zheng Q, Xu F, Nie M, Xia W, Qin T, Qin G, An X, et al. Selective estrogen receptor modulator-associated nonalcoholic fatty liver disease improved survival in patients with breast cancer: a retrospective cohort analysis. Medicine (Baltimore) 2015; 94: e1718. (Among 785 women with breast cancer treated with tamoxifen or toremifene for 2 to 10 years, 158 [20%] developed fatty liver disease [18% on tamoxifen vs 22% on toremifene] and 5 year disease-free survival was better in those who developed NAFLD [92%] than in those who did not [85%]). 26448028
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury in the US collected between 2004 and 2012, 4 cases were attributed to tamoxifen, but none to toremifene or other selective estrogen receptor modulators). 25754159
Ellis AJ, Hendrick VM, Williams R, Komm BS. Selective estrogen receptor modulators in clinical practice: a safety overview. Expert Opin Drug Saf 2015; 14: 921-34. (Review of the safety of SERMs focusing upon breast, uterine and cardiovascular adverse events; no mention of ALT elevations or liver disease). 25936229
Yang YJ, Kim KM, An JH, Lee DB, Shim JH, Lim YS, Lee HC, et al. Clinical significance of fatty liver disease induced by tamoxifen and toremifene in breast cancer patients. Breast 2016; 28: 67-72. (Among 1061 women with breast cancer and normal baseline ALT levels seen over a 1 year period in an Asian medical center, ALT elevations occurred in 45 of 618 [7.7%: peak values 46-237 U/L] who received SERMs vs 22 of 406 [4.5%] who did not; furthermore, fatty liver by imaging tests was found in 47 of 122 [42%] on SERM therapy vs 19 of 95 [20%] controls; nevertheless, no patient developed cirrhosis or died of liver disease). 27240168

## OTHER REFERENCE LINKS

1. Recent References on Toremifene: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Toremifene/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Toremifene: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Toremifene)